# Acyclovir

## OVERVIEW

### Introduction

Acyclovir is a nucleoside analogue and antiviral agent used in therapy of herpes and varicella-zoster virus infections. Acyclovir has not been associated with clinically apparent liver injury.

### Background

Acyclovir (ay sye' kloe vir) is an acyclic purine nucleoside analogue (acycloguanosine) which has antiviral activity against many herpes viruses, including herpes simplex 1 and 2, cytomegalovirus, Ebstein-Barr virus and varicella-zoster. Acyclovir is phosphorylated intracellularly by viral kinases, and the resultant triphosphate competes with guanosine for incorporation into viral DNA blocking viral DNA polymerase activity. Acyclovir is indicated for therapy of localized as well as disseminated herpes simplex infections, both type 1 and 2. It is also used for varicella-zoster infections (chickenpox and shingles). Acyclovir was approved for use in herpes virus infections in the United States in 1982, and is still widely used in treatment and prophylaxis of genital and mucocutaneous herpes simplex infection with almost 5 million prescriptions filled yearly. Acyclovir is available as capsules of 200 mg, tablets of 400 and 800 mg, oral suspensions, creams, ointments, and parenteral preparations in several generic forms, as well as under the brand name of Zovirax. The typical recommended oral dose in adults for genital or oral herpes simplex is 200 to 800 mg three to five times daily for 5 to 10 days; the usual prophylactic dose is 400 mg twice daily. The typical intravenous doses for severe infections is 5 to 10 mg/kg every 8 hours for 5 to 10 days. Side effects are uncommon with oral formulations, but can include myalgias, rash, temors, lethargy and confusion. Rare side effects include bone marrow toxicity and Stevens Johnson syndrome.

### Hepatotoxicity

Despite widespread use, there is little evidence that acyclovir when given orally causes significant liver injury. Serum enzyme levels generally do not change during oral acyclovir therapy. High dose intravenous administration of acyclovir is associated with renal dysfunction and thrombocytopenia, and occasionally with transient mild-to-moderate elevations in serum ALT levels, which have been asymptomatic and self-limited. There have rare instances of acute, clinically apparent liver injury reported that were attributed to acyclovir or valacyclovir (a prodrug of acyclovir with better oral absorption), but these have not been particularly convincing. Some degree of liver injury and even jaundice can occur during the course of herpes simplex or varicella zoster infection, and these complications could be mistaken for drug induced liver injury. Furthermore, in the reported cases, patients were receiving other medications and had other unlying comorbidities that may have been responsible for the liver injury.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Acyclovir is metabolized intracellularly in viral infected cells and is minimally metabolized by the liver. Acyclovir is excreted largely unchanged by the kidneys, perhaps accounting for the absence or rarity of hepatic injury.

Drug Class: Antiviral Agents

Other Antiviral Agents for Herpes Virus Infections: Cidofovir, Famciclovir, Foscarnet, Ganciclovir, Letermovir, Valacyclovir, Valganciclovir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acyclovir – Zovirax®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acyclovir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acyclovir | 59277-89-3 | C8-H11-N5-O3 | Acyclovir Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 February 2016

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; mentions that acyclovir has not caused "overt hepatic injury").
Nunez M. Herpesviridae treatment. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 512-3. (Review of hepatotoxicity of antiviral agents; mentions that there have been postmarketing reports of ALT elevaitons, hepatitis and jaundice due to acyclovir).
Acosta EP, Flexner C. Antiviral agents(nonretroviral). In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1593-1622. (Textbook of pharmacology and therapeutics).
Straus SE, Takiff HE, Seidlin M, Bachrach S, Lininger L, Di Giovanna JJ, Western KA, et al. Suppression of frequently recurring genital herpes. A placebo-controlled double-blind trial of oral acyclovir. N Engl J Med 1984; 310: 1545-50. (Placebo controlled trial of acyclovir in 35 patients with recurrent genital herpes; one patient had ALT elevations [88 U/L] that resolved even during continuation of therapy). 6328297
O'Brien JJ, Campoli-Richards DM. Acyclovir. An updated review of its antiviral activity, pharmacokinetic properties and therapeutic efficacy. Drugs 1989; 37: 233-309. (Review of antiviral activity, mechanism of action, pharmacokinetics, clinical efficacy and adverse effects of acyclovir; side effects are usually mild, but high doses intravenously are associated with nausea, vomiting, lightheadedness, neurologic symptoms, and renal dysfunction; no mention of hepatotoxicity or ALT elevations). 265379
Tilson HH, Engle CR, Andrews EB. Safety of acyclovir: a summary of the first 10 years experience. J Med Virol 1993; Suppl 1: 67-73. (Between 10-15 million persons have been treated with acyclovir, but the sponsor received only 923 adverse event reports: 129 considered serious, but no specific mention of hepatotoxicity or ALT elevations). 8245895
Styrt B, Freiman JP. Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am 1995; 24: 839-52. (Review of liver toxicity of antiviral agents; acyclovir may be associated with minor liver test elevations, but there have been no published reports of it causing clinically apparent liver injury). 8749901
Ormrod D, Scott LJ, Perrry CM. Valaciclovir: a review of its long term utility in the management of genital herpes simplex virus and cytomegalovirus infections. Drugs 2000; 59: 839-63. (Review of efficacy and safety of long term valaciclovir use; rates of side effects are similar in frequency to those in patients on placebo; a single case of hepatitis due to valaciclovir has been reported in abstract form). 10804039
Bodsworth NJ, Crooks RJ, Borelli S, Vejlsgaard G, Paavonen J, Worm A-M, Uexkull N, et al., International Valaciclovir HSV Study Group. Genitourin Med 1997; 73: 110-6. (999 patients randomized at 48 sites to acyclovir or valacyclovir for 5 days for recurrent HSV infection; equivalent efficacy and "no clinically important changes from screening in any clinical chemistry variable"). 9215092
Renkes P, Trechot P, Blain H. Valaciclovir-induced hepatitis. Acta Clin Belg 1999; 54: 17-8. (71 year old woman with shingles developed abdominal pain 7 days after starting valacyclovir and 3 g/day of acetaminophen [bilirubin 3.3 mg/dL, ALT 376 U/L, Alk P 246 U/L], resolving within 2 weeks of stopping). 10192972
Simpson D, Lyseng-Williamson KA. Famciclovir: a review of its use in herpes zoster and genital and orolabial herpes. Drugs 2006; 66: 2397-416. (Review of famciclovir, oral prodrug of penciclovir, used in herpes zoster and simplex virus infections for limited period as therapy and extended use for suppression; in suppression studies, ALT elevations above twice ULN occurred in 3.2% of famciclovir vs 1.5% of placebo recipients; no hepatic serious adverse events reported). 17181386
Drugs for non-HIV viral infections. Treat Guidel Med Lett 2007; 5: 59-70. (Review of status of non-antiretroviral antiviral agents for prevention and treatment of herpes, varicella-zoster, cytomegalovirus, influenza A and B, and hepatitis B and C; no mention of liver related side effects for acyclovir). 17565338
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antiviral agents including one attributed to valacyclovir, but none to acyclovir). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 4 of which were due to antiretroviral agents, but none were attributed to an antiherpes virus agent). 20949552
Antiviral drugs. Treat Guidel Med Lett 2013; 11 (127): 19-30. (Review of safety and efficacy of acyclovir treatment and prophylaxis against varicella and herpes zoster infections; mentions oral acyclovir has been linked to cases of Stevens Johnson syndrome, but does not specifically mention liver injury). 23459414
Gopal MG, Shannoma, Kumar B C S, M R, A S N, Manjunath NC. A comparative study to evaluate the efficacy and safety of acyclovir and famciclovir in the management of herpes zoster. J Clin Diagn Res 2013; 7: 2904-7. (Among 100 patients with herpes zoster treated for 7 days with either acyclovir or famciclovir, there was no "clincally significant difference" in serum biochemistry tests between the two groups). 24551671
Pugi A, Bonaiuti R, Maggini V, Moschini M, Tuccori M, Leone R, Rossi M, et al. Safety profile of antiviral medications: a pharmacovigilance study using the Italian spontaneous-reporting database. Am J Health Syst Pharm 2013; 70: 1039-46. (Analysis of adverse drug events reported spontaneous during a 22 year period in Italy identified 863 reports involving antivirals, but liver related events were not among the 20 most reported reactions). 23719881
Tachibana T, Nozaki A, Enaka M, Yamamoto E, Kawasaki R, Koharazawa H, Hagihara M, et al. Drug-induced liver injury after allogeneic bone marrow transplantation. Int J Hematol 2013; 98: 499-503. (23 year old woman with acute leukemia and allogeneic bone marrow transplant developed jaundice [bilirubin 14.0 mg/dL, ALT 1379 U/L, Alk P 1389 U/L] 180 days after transplant, while receiving oral acyclovir [for 104 days], voriconazole [60 days] and rebamipide [97 days], as well as tacrolimus and lansoprazole; a positive lymphocyte stimulation test was found for acyclovir, but not the other agents). 24037455
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to acyclovir or any other antiviral agent). 23419359
Kendrick JG, Ensom MH, Steer A, White CT, Kwan E, Carr RR. Standard-dose versus high-dose acyclovir in children treated empirically for encephalitis: a retrospective cohort study of its use and safety. Paediatr Drugs 2014; 16: 229-34. (Among 61 children with herpes simplex encephalitis treated with high or standard doses of intravenous acyclovir, "elevated liver enzymes" occurred in 4 [6.5%], 2 at each dose level; no mention of outcome, symptoms or jaundice). 24497110
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to acyclovir but its likelihood was judged to be only possible). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Acyclovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Acyclovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Acyclovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acyclovir)